# Ravulizumab

## OVERVIEW

### Introduction

Ravulizumab is a humanized monoclonal antibody to complement factor 5 which acts to block complement activation and is used to treat paroxysmal nocturnal hemoglobinuria. Ravulizumab has not been linked to serum enzyme elevations during therapy or to instances of idiosyncratic acute liver injury.

### Background

Ravulizumab (rav" ue liz' ue mab) is a recombinant, humanized IgG monoclonal antibody to complement factor 5, which inhibits its enzymatic cleavage and activation. Activated complement is an important mediator of immune damage including hemolysis of red blood cells and plays an essential role in the hemolysis and tissue damage that accompanies paroxysmal nocturnal hemoglobinuria (PNH). In clinical trials in PNH, ravulizumab was found to reduce hemolysis and the need for blood transfusions with subsequent improvement in symptoms and quality of life. Ravulizumab was approved for use in PNH in the United States in 2018. Ravulizumab is available as a solution in single dose vials of 300 mg in 30 mL (10 mg/mL) under the commercial name Ultomiris. Ravulizumab is given by intravenous infusion, the dose varying by body weight, with a recommended loading dose of 2,400 to 3,000 mg followed 2 weeks later by maintenance dose of 3,000 to 3,600 mg every 8 weeks thereafter. Ravulizumab was engineered to have a prolonged half-life allowing for an every-8-week maintenance regimen in contrast to the every-2-week regimen required for eculizumab, a similar monoclonal antibody to complement factor 5 that was approved for use in PNH in 2007. Side effects are not common, but can include headache, diarrhea, nausea, fatigue and upper respiratory tract infections. Rare, but potentially severe adverse reactions include serious infections, including meningococcal infections, for which reason eculizumab is available only as a part of a risk evaluation and mitigation strategy (REMS) that requires physician training in its use and enrollment of the patient in a surveillance program.

### Hepatotoxicity

In clinical trials of comparing ravulizumab and eculizumab in patients with PNH, serum enzyme levels were rarely mentioned, and laboratory test results were described as being stable or unremarkable. Summaries of preregistration trials of ravulizumab vs eculizumab commented that there were “no notable differences in changes in clinical chemistry or hematology parameters” and no patient discontinued therapy because of adverse events. Clinical use of ravulizumab has been limited, but there have been no reports of clinically apparent liver injury associated with its use. Acute self-limited liver injury with jaundice has, however, been reported with eculizumab (a similar monoclonal antibody to complement factor 5) therapy of hemolytic uremic syndrome in children. Affected children were able to continue or resume the monoclonal therapy after resolution of the injury without recurrence, and neither ravulizumab or eculizumab have been linked to cases of acute liver failure or chronic liver injury.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which ravulizumab might cause liver injury is unknown. Ravulizumab is a monoclonal antibody and, like other proteins, is metabolized into amino acids and is unlikely to have intrinsic toxicity. Because it blocks the activation of complement, it might predispose to conditions that depend on complement activation for resolution (such as meningococcemia), but it is not clear whether this applies to any liver diseases.

### Outcome and Management

Ravulizumab therapy has been linked to rare instances of mild, transient serum enzyme elevations, but cases of jaundice and symptoms from liver injury with ravulizumab therapy have not been described. In patients who develop persistent, marked elevations of serum ALT or alkaline phosphatase or who develop jaundice and symptoms, therapy should be interrupted.

Drug Class: Hematologic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ravulizumab – Ultomiris®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ravulizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ravulizumab | 1803171-55-2 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 12 April 2019

Abbreviations used: HUS, hemolytic uremic syndrome; PNH, paroxysmal nocturnal hemoglobinuria.

Zimmerman HJ. Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of monoclonal immunosuppressive agents; mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; ravulizumab is not specifically mentioned).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that clinical trials comparing therapy with ravulizumab to eculizumab found “no notable differences in changes in clinical chemistry or hematology parameters”).
Hillmen P, Lewis SM, Bessler M, Luzzatto L, Dacie JV. Natural history of paroxysmal nocturnal hemoglobinuria. N Engl J Med 1995; 333: 1253-8. (Among 80 patients with PNH seen at a single London referral center between 1940 and 1970, ages 16 to 73 at diagnosis, the median survival was 10 years and causes of death were often hemorrhage or serious thrombotic events). 7566002
Brodsky RA. Paroxysmal nocturnal hemoglobinuria. Blood 2014; 124: 2804-11. (Review of the pathophysiology, genetic causes, diagnosis, classification, clinical features and treatment of PNH; no mention of adverse effects of eculizumab). 25237200
Hayes W, Tschumi S, Ling SC, Feber J, Kirschfink M, Licht C. Eculizumab hepatotoxicity in pediatric aHUS. Pediatr Nephrol 2015; 30: 775-81. (Among 11 children with atypical HUS treated with eculizumab, liver test abnormalities above 3 times ULN arose in 5 children after 1-4 doses [peak direct bilirubin 0.5-9.9 mg/dL, ALT 129-908 U/L, AST 244-1039 U/L, Alk P 173-1023, all values having been normal before treatment], which resolved despite continuing therapy in 4 who were asymptomatic, but required discontinuation in one who became jaundiced and symptomatic but recovered upon stopping after a third dose). 25416628
Röth A, Rottinghaus ST, Hill A, Bachman ES, Kim JS, Schrezenmeier H, Terriou L, et al. Ravulizumab (ALXN1210) in patients with paroxysmal nocturnal hemoglobinuria: results of 2 phase 1b/2 studies. Blood Adv 2018; 2: 2176-85. (Among 39 patients with PNH treated with ravulizumab with varying doses and frequencies [every 2, 4, 6 ,8 or 12 weeks], adverse events were common but well tolerated, most commonly headache, and two subjects developed meningococcal infections; no mention of ALT elevations or hepatotoxicity). 30171081
Lee JW, Sicre de Fontbrune F, Wong Lee L, Pessoa V, Gualandro S, Füreder W, Ptushkin V, et al. Ravulizumab (ALXN1210) vs eculizumab in adult patients with PNH naive to complement inhibitors: the 301 study. Blood 2019; 133: 530-9. (Among 246 treatment-naïve patients with PNH treated with either ravulizumab [every 8 weeks] or eculizumab [every 2 weeks] for 6 months, response rates were similar in the two groups as were adverse events including headache [36% and 33%], serious infections [16% vs 3.3%], and discontinuations [0% vs 1.6%], and there were no serious hepatic adverse events or discontinuations because of serum enzyme elevations). 30510080
Kulasekararaj AG, Hill A, Rottinghaus ST, Langemeijer S, Wells R, Gonzalez-Fernandez FA, Gaya A, et al. Ravulizumab (ALXN1210) vs eculizumab in C5-inhibitor-experienced adult patients with PNH: the 302 study. Blood 2019; 133: 540-9. (Among 195 patients with PNH on long term eculizumab therapy, need for transfusions and rates of hemolysis remained low both in those who remained on eculizumab and those who were switched to ravulizumab and adverse event rates are similar; no mention of ALT elevations or hepatotoxicity). 30510079

## OTHER REFERENCE LINKS

1. Recent References on Ravulizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ravulizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ravulizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ravulizumab)